# Isocarboxazid

## OVERVIEW

### Introduction

Isocarboxazid is a monoamine oxidase inhibitor (MAO inhibitor) used in therapy of severe depression. Isocarboxazid therapy is associated with rare instances of clinically apparent acute liver injury.

### Background

Isocarboxazid (eye" soe kar box' a zid) is a hydrazine antidepressant that acts through inhibition of monoamine oxidase, an enzyme that inactivates several neurotransmitter amines such as norepinephrine and serotonin. By inhibition of catabolism of serotonin and norepinephrine, isocarboxazid increases brain levels of these neurotransmitters which probably underlie its antidepressant effects. Isocarboxazid was approved for use as therapy of depression in the United States in 1959, but it is now rarely used because of the availability of more potent and better tolerated antidepressants such as the tricyclic antidepressants and the selective serotonin reuptake inhibitors. Isocarboxazid is available in generic forms and under the brand name of Marplan as tablets of 10 mg. The usual initial adult dose of isocarboxazid is 10 mg twice daily, with increase in the dose based upon efficacy and tolerance to a maximum of 60 mg per day. Common side effects include drowsiness, dizziness, headache, insomnia, tremor, dry mouth, nausea, increased appetite, weight gain and sexual dysfunction. Isocarboxazid interacts with many medications as well as many foods and beverages, and patients require careful monitoring and education. Rare but potentially severe adverse events associated with MAO inhibitors include suicidal ideation and behavior, hypertensive crises, serotonin syndrome, activation of mania, withdrawal syndrome, and hypersensitivity reactions.

### Hepatotoxicity

Isocarboxazid, like most monoamine oxidase (MAO) inhibitors, can cause transient serum aminotransferase elevations in a proportion of patients. These elevations are usually mild, asymptomatic and self-limited and do not require dose modification. MAO inhibitors have been associated with rare cases of acute, clinically apparent liver injury but isocarboxazid has not specifically been implicated. The time to clinical onset of liver injury due to MAO inhibitors is typically 1 to 4 months after starting and the usual pattern of serum enzyme elevations is hepatocellular, although cholestatic injury has also been described. Immunoallergic features (rash, fever, eosinophilia) are uncommon as is autoantibody formation. Isocarboxazid has not been directly implicated in cases of drug-induced liver injury but it has had limited clinical use.

Likelihood score: E* (unproven, but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which isocarboxazid causes serum aminotransferase elevation is not known. It undergoes extensive hepatic metabolism and a possible cause of liver injury is production of a toxic intermediate of metabolism.

### Outcome and Management

The serum aminotransferase elevations that occur on isocarboxazid and on other MAO inhibitor therapy are usually self-limited and do not require dose modification or discontinuation of therapy. The acute liver injury caused by MAO inhibitors is typically self-limited, but progressive and fatal instances of acute hepatitis have been reported with phenelzine. Rechallenge usually causes a prompt recurrence of the liver injury and should be avoided. Patients with isocarboxazid induced liver injury are likely to have cross sensitivity to other monoamine oxidase inhibitors, but should be able to tolerate tricyclic antidepressants or selective serotonin reuptake inhibitors.

Drug Class: Antidepressant Agents

Other Drugs in the Subclass, MAO Inhibitors: Phenelzine, Tranylcypromine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Isocarboxazid – Generic, Marplan®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=isocarboxazid)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Isocarboxazid | 59-63-2 | C12-H13-N3-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 08 April 2020

Abbreviations: MAO, monoamine oxidase; SSRI, selective serotonin reuptake inhibitor; SNRI, serotonin and norepinephrine reuptake inhibitor.

Zimmerman HJ. Antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 493-8. (Expert review of hepatotoxicity of antidepressants published in 1999; hepatic injury caused by MAO inhibitors is similar to that of isoniazid with which they share structural similarity as hydrazines; the pattern of injury is typically hepatocellular and arises within 1-6 months of starting therapy; cases of fatal acute liver failure have been described, most commonly with iproniazid and less commonly with phenelzine and isocarboxazid, and least commonly with the nonhydrazide MAO inhibitor, tranylcypromine).
Larrey D, Ripault M-P. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of MAO inhibitors and liver injury which was most common with iproniazid, which has been withdrawn; isocarboxazid is not mentioned).
O'Donnell JM, Bies RR, Shelton RC. Drug therapy of depression and anxiety disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 267-77. (Textbook of pharmacology and therapeutics; the MAO inhibitors were the first antidepressants in clinical medicine, but inhibit both MAO-A and MAO-B which results in major drug and food interactions; specific MAO-B inhibitors are used for Parkinson disease, specific MAO-A inhibitors have been developed but are not available in the US).
Rosenblum LE, Korn RJ, Zimmerman HJ. (1960). Hepatocellular jaundice as a complication of iproniazid therapy. Arch Intern Med. (Classic paper on iproniazid hepatotoxicity; review of 90 patients; more common in women, ages 25-75 years, onset in 1-4 months [~95%], usually hepatocellular pattern similar to viral hepatitis, 22% mortality and demonstration that this is higher than in acute viral hepatitis).
Crisp AH, Hays P, Carter A. (1961). Three amine-oxidase inhibitor drugs in the treatment of depression. Relative value and toxic effects. Lancet. (Prospective study of liver test abnormalities during courses of iproniazid [n=17], nialamide [18] and peniprazine [20], with minor increases noted; no data on frequency of levels above normal).
Knight JA. (1961). Drug-induced hepatic injury. Marplan hepatitis. Am J Psychiatry. (23 year old woman developed jaundice 4 months after starting isocarboxazid [bilirubin 6.8 mg/dL, ALT 540 U/L, Alk P 3 time ULN], resolving within a few months of stopping).
Cook GC, Sherlock S. (1965). Jaundice and its relation to therapeutic agents. Lancet. (Cases of drug induced liver disease seen at Royal Free Hospital from 1959-65; 11 cases of acute liver failure due to drugs including iproniazid [n=3], phenelzine [2], phenoxypropazine [2], prochlorperazine [1] and halogenated anesthetics [3]; 20 cases of cholestatic hepatitis due to drugs, 18 due to chlorpromazine, 1 perphenazine and 1 nitrofurantoin).
Steingart AB, Cotterchio M. (1995). Do antidepressants cause, promote, or inhibit cancers?. J Clin Epidemiol. (Conflicting data from animal studies and epidemiological surveys have provided little evidence of a link between antidepressant use and breast, liver or other cancer after control for confounding variables).
Lucena MI, Carvajal A, Andrade RJ, Velasco A. (2003). Antidepressant-induced hepatotoxicity. Expert Opin Drug Saf. (Review of hepatotoxicity of antidepressants; antidepressant use has increased markedly between 1992 and 2002, accounting for 5% of cases of hepatotoxicity; MAO inhibitors were first antidepressants developed; iproniazid caused a severe hepatitis and was withdrawn; phenelzine is still is in use, but has been associated with severe cases of hepatitis and development of cirrhosis).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 2 to antidepressants [venlafaxine and fluoxetine], but none to MAO inhibitors).
Park SH, Ishino R. (2013). Liver injury associated with antidepressants. Curr Drug Saf. (Review of the commonly used antidepressants and their potential for causing liver injury does not discuss the MAO inhibitors).
Shulman KI, Herrmann N, Walker SE. (2013). Current place of monoamine oxidase inhibitors in the treatment of depression. CNS Drugs. (History of the discovery that hydrazine-based drugs had potent antidepressant activity and subsequent development of nonspecific and specific, irreversible and reversible MAO A and B inhibitors which have similar antidepressant effects but different relative risks for complications such as hypertension from dietary intake of tyramine [as in aged cheese] and serotonin syndrome from use of a second serotonin-enhancing agent, such as a tricyclic, SSRI or SNRI as well as some opiates).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, one of which was attributed to an tricyclic antidepressant [amitriptyline], but none to MAO inhibitors).
Voican CS, Corruble E, Naveau S, Perlemuter G. (2014). Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry. (Review of hepatotoxicity of antidepressants, mentions reports of hepatoxicity and rates of ALT elevations due to MAO inhibitors including iproniazid, phenelzine and modobemide, but not isocarboxazid).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases [2%] were attributed to antidepressants, but none to MAO inhibitors).
Friedrich ME, Akimova E, Huf W, Konstantinidis A, Papageorgiou K, Winkler D, Toto S, et al. (2016). Drug-induced liver injury during antidepressant treatment: results of AMSP, a drug surveillance program. Int J Neuropsychopharmacol. (Among 184,234 psychiatric inpatients from 80 hospitals, 149 cases [0.08%] of drug induced liver injury were reported, with 3 cases occurring among 3860 subjects receiving MAO inhibitors, all 3 receiving tranylcypromine [0.08%]).
Ferrajolo C, Scavone C, Donati M, Bortolami O, Stoppa G, Motola D, Vannacci A, et al., DILI-IT Study Group. (2018). Antidepressant-induced acute liver injury: a case-control study in an Italian inpatient population. Drug Saf. (Among 179 cases of hospitalizations for unexplained acute liver injury enrolled in an prospective study between 2010 and 2014, 17 had been exposed to antidepressants most commonly citalopram, paroxetine and sertraline; none were taking an MAO inhibitor).
(2020). Drugs for depression. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of drugs for depression, mentions that tricyclics and MAO inhibitors remain valuable alternatives for treatment of moderate-to-severe depression, despite concerns about their safety; hepatotoxicity is mentioned only for nefazodone [now rarely used because of severe hepatotoxicity] and duloxetine [in heavy drinkers]).

## OTHER REFERENCE LINKS

1 Recent References on Isocarboxazid: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(isocarboxazid/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Isocarboxazid: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=isocarboxazid)